# Cannabidiol

## OVERVIEW

### Introduction

Cannabidiol (CBD) is a non-psychoactive component of Cannabis sativa (marijuana), one of more than 80 cannabinoids identified in the plant, and the second most common constituent after Δ^9^-tetrahydrocannabinol (THC), the major psychoactive component. Cannabidiol is available as an FDA approved prescription medication (Epidiolex) used in moderately high doses for severe forms of epilepsy, but it is also widely available as over-the-counter CBD oils, gummies, topical creams or vaping solutions. High daily doses of cannabidiol are associated with frequent serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice. The lower doses of cannabidiol found typically in over-the-counter CBD products are generally well tolerated without evidence of liver injury.

### Background

Cannabidiol (kan" a bi dye' ol) is a natural cannabinoid, the second most common component in Cannabis sativa (marijuana). Unlike the most abundant cannabinoid, delta-9-tetrahydrocannabinol (THC), the psychoactive ingredient of marijuana, cannabidiol has minimal psychoactive properties and may actually decrease the risk of psychotic symptoms and impaired cognition after cannabis use. The mechanism of action of cannabidiol is unknown, but it may be a partial agonist of cannabinoid receptors. Cannabidiol in moderately high doses was found to reduce the frequency of seizures in treatment-resistant epilepsy, particularly in patients with Lennox-Gastaut or Dravet syndrome, two rare but severe childhood onset forms of epilepsy. Cannabidiol was approved for use in the United States in 2018. Current indications are limited to treatment of seizures associated with Lennox-Gastaut or Dravet syndrome in adults and in children above the age of two. Cannabidiol is available as an oral solution of 100 mg/mL under the brand name Epidiolex. The typical dose is 2.5 mg/kg twice daily, which can be increased based upon tolerance and effect to 5 mg/kg twice daily and to a maximum of 10 mg/kg twice daily. The dose should be reduced in patients with preexisting hepatic impairment. Side effects are mostly dose related and can include fatigue, somnolence, dizziness, sleep disturbance, insomnia, anorexia, weight loss, diarrhea, infections and rash. Rare, but potentially severe side effects include marked sedation and somnolence, suicidal behavior and ideation and hypersensitivity reactions. Cannabidiol is generally used in combination with other anticonvulsants and is prone to drug-drug interactions that may affect drug levels and side effects of those agents, particularly valproate and clobazam.

Cannabidiol as found in over-the-counter products such as CBD oil, gummies or vaping solutions is largely unregulated and often of uncertain concentration and purity. Cannabidiol can be derived from hemp, a Cannabis sativa species with low levels of THC, typically <0.3%, compared to 15% in marijuana. Various forms of cannabidiol have been marketed as having analgesic, antiinflammatory, anxiolytic, antipsychotic and antiarthritic effects, but none of these have been definitely proven in prospective, properly designed studies. Furthermore, the concentration of CBD in most products is not known and varies widely as do low or trace amounts of THC and other contaminants. As a consequence, the purported activities of CBD may actually be effects of THC, accounting for the anecdotal reports of its effects on pain, anxiety, and sleep. The concentration of CBD in these nonprescription forms has generally been less than those in the FDA approved form used in epilepsy (Epidiolex) and daily doses are in the range of 25 to 300 mg daily. Prospective studies of CBD in daily doses of less than 400 mg have generally found few beneficial effects, but also few adverse events except for mild somnolence and dizziness.

### Hepatotoxicity

In prelicensure studies, serum aminotransferase elevations arose during cannabidiol therapy for epilepsy in 34% to 47% of patients compared to 18% of controls who were receiving other anticonvulsant medications. Elevations above 3 times ULN occurred in 13% of cannabidiol treated compared to 1% on placebo. ALT and AST elevations were more frequent with higher doses and were particularly common (and sometimes delayed) in patients who were receiving valproate and clobazam. The aminotransferase elevations typically arose within the first two months of treatment and were transient, mild-to-moderate in severity, and not associated with symptoms or jaundice. There have been no convincing reports of clinically apparent liver injury with jaundice attributable to prescription forms of cannabidiol, but it has had very limited general use.

There have been few studies of liver test abnormalities during therapy with lower doses of CBD or with commercially available, over-the-counter CBD products. In doses between 200 and 400 mg daily, mild-to-moderate serum aminotransferase elevations have occasionally been reported, but there have been no reports of clinically apparent liver injury. Furthermore, liver injury arising in persons taking supplements with CBD must also consider the possibility of contaminants in the products or other herbal and dietary supplement use.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury, particularly with high doses).

### Mechanism of Injury

The cause of serum aminotransferase elevations during cannabidiol therapy in doses used to treat epilepsy is not known, but may represent direct toxicity and be due to the molecule itself or to the production of a toxic intermediate in its metabolism. Cannabidiol is metabolized by the liver in large part by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce or inhibit CYP 3A4 activity.

### Outcome and Management

High dose cannabidiol therapy can be associated with serum ALT and AST elevations that generally arise within the first 2 months of treatment and are mild-to-moderate in severity. The frequency of elevations is dose related and more frequent when given in combination with valproate and clobazam. The elevations, however, are generally asymptomatic, self-limited in course and not associated with jaundice. Nevertheless, routine monitoring of liver tests is recommended before starting and at 1, 3 and 6 months during treatment as well as periodically thereafter, particularly in patients who are also receiving valproate. Cannabidiol should be discontinued if there are ALT elevations accompanied by symptoms of jaundice or if the levels rise and persist at more than 5 times ULN.

Drug Class: Anticonvulsants; Marijuana

Other Related Cannabinoid Agents: Dronabinol, Nabilone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cannabidiol – Epidiolex®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cannabidiol+&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cannabidiol | 13956-29-1 | C21-H30-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Abbreviations used: AIDS, acquired immune deficiency syndrome; CB, cannabinoids; CBD, cannabidiol; THC, Δ^9^ tetrahydrocannabinol.

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Hepatotoxicity: The adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams and Wilkins, 1999, p. 721. (Expert review of hepatotoxicity published in 1999 does not discuss cannabidiol).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210365Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; cannabidiol caused dose related elevations in ALT arising in 52% of patients and to above 5 times ULN in 6%, occurring most frequently when given with valproate and sometimes with delayed onset, but no case was associated with concurrent significant bilirubin elevations).
Devinsky O, Marsh E, Friedman D, Thiele E, Laux L, Sullivan J, Miller I, et al. (2016). Cannabidiol in patients with treatment-resistant epilepsy: an open-label interventional trial. Lancet Neurol. (Among 162 patients [ages 1 to 30 years] with intractable, childhood-onset epilepsy who were treated with cannabidiol for at least 12 weeks, the frequency of seizures decreased by 37% while adverse events included somnolence [25%], anorexia [19%] diarrhea [19%], fatigue [13%] and elevated liver tests [7%] which led to early discontinuation in patients on valproate).
McGuire P, Robson P, Cubala WJ, Vasile D, Morrison PD, Barron R, Taylor A, et al. (2018). Cannabidiol (CBD) as an adjunctive therapy in schizophrenia: a multicenter randomized controlled trial. Am J Psychiatry. (Among 88 patients with schizophrenia in a placebo controlled trial for 6 weeks, clinical improvements were more frequent with cannabidiol [1000 mg daily] than placebo, as were adverse events including diarrhea [9% vs 4%] and nausea [7% vs 0%]).
Thiele EA, Marsh ED, French JA, Mazurkiewicz-Beldzinska M, Benbadis SR, Joshi C, Lyons PD, et al., GWPCARE4 Study Group. (2018). Cannabidiol in patients with seizures associated with Lennox-Gastaut syndrome (GWPCARE4): a randomised, double-blind, placebo-controlled phase 3 trial. Lancet. (Among 171 patients with treatment resistant seizures due to Lennox-Gastaut syndrome in a 14 week placebo controlled trial, seizure frequency decreased by 44% with cannabidiol vs 22% in controls and side effects included diarrhea [19% vs 8%], somnolence [15% vs 9%], fatigue [6% vs 2%] and ALT elevations [9% vs 2%]).
Devinsky O, Patel AD, Thiele EA, Wong MH, Appleton R, Harden CL, Greenwood S, et al. (2018). GWPCARE1 Part A Study Group. Randomized, dose-ranging safety trial of cannabidiol in Dravet syndrome. Neurology. (Among 34 patients with refractory seizures due to Dravet syndrome treated with cannabidiol [5, 10 or 20 m/kg/day] or placebo, 6 of 27 [22%] on cannabidiol developed ALT elevations above 3 times ULN [all on valproate], which resolved in all but led to early drug discontinuation in one subject).
Devinsky O, Patel AD, Cross JH, Villanueva V, Wirrell EC, Privitera M, Greenwood SM, et al., GWPCARE3 Study Group. (2018). Effect of cannabidiol on drop seizures in the Lennox-Gastaut syndrome. N Engl J Med. (Among 225 patients [ages 2 to 55 years] with refractory drop seizures due to Lennox-Gastaut syndrome enrolled in a 14 week placebo controlled trial, seizure frequency decreased more with cannabidiol [-37% at 10 mg and -42% at 20 mg per kg daily] than placebo [-17%], while adverse events were more frequent including somnolence [21-30% vs 5%], anorexia [16-26% vs 8%] and diarrhea [10-15% vs 8%], and ALT elevations were the most common reason for drug discontinuation, although no patient developed clinically apparent liver injury or jaundice).
Szaflarski JP, Bebin EM, Comi AM, Patel AD, Joshi C, Checketts D, Beal JC, et al., CBD EAP study group. (2018). Long-term safety and treatment effects of cannabidiol in children and adults with treatment-resistant epilepsies: Expanded access program results. Epilepsia. (Among 607 patients [ages <1 to 62 years] with treatment-resistant epilepsy treated with cannabidiol in an expanded access program with median treatment of 48 weeks, seizure frequency decreased by 51% and common adverse events were diarrhea [29%], somnolence [22%], anorexia [12%] and fatigue [11%]; ALT or AST elevations above 3 times ULN arose in 61 subjects [10%], most of whom [n=46] were also receiving valproate, but there were no instances of clinically apparent liver injury).
Hazekamp A. (2018). The trouble with CBD oil. Med Cannabis Cannabinoids. (Commentary on the uncertainties of the efficacy, safety and purity of cannabidiol marketed products).
Bar-Lev Schleider L, Mechoulam R, Saban N, Meiri G, Novack V. (2019). Real life experience of medical cannabis treatment in autism: analysis of safety and efficacy. Sci Rep. (Among 188 patients with autism spectrum disorders treated with miscellaneous cannabis products [usually consisting of 30% CBD and 1.5% THC, given 3 times daily] between 2015 and 2017 in Israel, 49% reported significant improvement, 31% moderate improvement, 6% side effects and 14% no change; no mention of ALT elevations or hepatotoxicity).
Thiele E, Marsh E, Mazurkiewicz-Beldzinska M, Halford JJ, Gunning B, Devinsky O, Checketts D, et al. (2019). Cannabidiol in patients with Lennox-Gastaut syndrome: Interim analysis of an open-label extension study. Epilepsia. (Among 366 patients who completed controlled trials of cannabidiol for Lennox-Gastaut syndrome and continued therapy for an average of 38 weeks, adverse events included diarrhea [27%] and somnolence [24%], while ALT or AST elevations above 3 times ULN arose in 21% of patients also receiving valproate but only 3.5% of those who were not, and no patient developed clinically apparent liver injury with jaundice although 1.5% stopped therapy because of ALT or AST elevations).
Schmitz SM, Lopez HL, Marinotti O. (2020). Post marketing safety of Plus CBD™ Products, a full spectrum hemp extract: a 2-year experience. J Diet Suppl. (Among 1334 spontaneous reports of adverse events arising during taking a commercial cannabidiol over a 2 year period, the most common adverse events were abdominal discomfort, headache, and hypersensitivity reactions; while only one report mentioned elevated liver enzymes).
Sholler DJ, Schoene L, Spindle TR. (2020). Therapeutic efficacy of cannabidiol (CBD): a review of the evidence from clinical trials and human laboratory studies. Curr Addict Rep. (Review of trials of CBD for efficacy in various conditions concludes that the evidence is lacking for many disease conditions except for epilepsy; no discussion of adverse events).
Chesney E, McGuire P, Freeman TP, Strang J, Englund A. (2020). Lack of evidence for the effectiveness or safety of over-the-counter cannabidiol products. Ther Adv Psychopharmacol. (Extensive review of the efficacy and safety of cannabidiol compares pharmaceutical grade to over-the-counter grade products, most of which are of uncertain purity and concentration and are used in lower doses [<300 mg/day], which are unlikely to achieve plasma levels associated with engagement of cannabinoid receptors and which have not consistently shown the effects of the higher doses of pharmaceutical grade cannabidiol that has been shown to reduce anxiety and psychiatric symptoms but also cause liver enzyme elevations, particularly when given with clobazam or valproate).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases of liver injury due to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90], Herbalife products [64], kava kava [62], and greater celandine [48]; cannabis and marijuana were not listed).
Kanjanarangsichai A, Mitarnun W, Mitarnun W, Pangwong W, Laoharattanahirun N, Kajornrith W, Junlaor P, et al. (2022). Cannabidiol-enriched cannabis extraction product in Parkinson's disease: a randomized, double-blind, and placebo-controlled trial in Buriram Hospital. J Neurosci Rural Pract. (Among 40 patients with Parkinson disease treated with a sublingual cannabinoid product [16 mg of cannabidiol and 0.6 mg of THC daily] for 8 weeks, there were no differences in measures of Parkinson disease symptoms and signs and no differences in serum ALT, AST, Alk P and bilirubin levels between the two groups).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while marijuana and cannabis were not implicated in any cases).
Nathan R, Mupamombe CT, Elibol J, Case AA, Smith D, Hyland A, Attwood K, et al. (2023). Assessing efficacy and use patterns of medical cannabis for symptom management in elderly cancer patients. Am J Hosp Palliat Care. (Among 85 cancer patients ages 65 years and above who were treated with medical cannabis products [containing both THC and CBD] who filled out symptom questionnaires before and during therapy there were slight decreases but no statistically significant changes in pain, nausea, anorexia or anxiety; no mention of adverse events, ALT elevations or hepatotoxicity).
Souza JDR, Pacheco JC, Rossi GN, de-Paulo BO, Zuardi AW, Guimarães FS, Hallak JEC, et al. (2022). Adverse effects of oral cannabidiol: an updated systematic review of randomized controlled trials (2020-2022). Pharmaceutics. (Systematic review of trials of CBD for safety and efficacy published in 2020 with data from 12 studies in 745 patients, reported adverse events of gastrointestinal symptoms in 60%, somnolence and loss of appetite in 17%, elevations in ALT or AST in 13% [above 3 times ULN in 6% all of whom were on other anticonvulsants], and rash in 1%).
Mboumba Bouassa RS, Needham J, Nohynek D, Singer J, Lee T, Bobeuf F, Samarani S, et al. (2022). Safety and tolerability of oral cannabinoids in people living with HIV on long-term ART: a randomized, open-label, interventional pilot clinical trial (CTNPT 028). Biomedicines. (A trial of 3 different cannabinoid products in only 10 patients, 2 of whom developed ALT elevations when the CBD dose was increased from 200 to 800 mg daily; to ~90 U/L in one resolving upon stopping and to >1000 U/L in the second who subsequently was found to have pancreatic cancer).
Erridge S, Holvey C, Coomber R, Hoare J, Khan S, Platt M, Rucker J, et al. (2023). Clinical outcome data of children treated with cannabis based medicinal products for treatment resistant epilepsy – analysis from the UK Medical Cannabis Registry. Neuropediatrics. Neuropediatrics. (Among 35 children with resistant epilepsy treated with medical cannabis based products, improved control of seizures was achieved in 66% and adverse events arose in 46% but were largely self-limited and mild; no mention of ALT levels or hepatotoxicity).
Englund A, Oliver D, Chesney E, Chester L, Wilson J, Sovi S, De Micheli A, et al. (2022). Does cannabidiol make cannabis safer? A randomised, double-blind, cross-over trial of cannabis with four different CBD:THC ratios. Neuropsychopharmacology. (Among 47 healthy volunteers given granulated cannabis after pretreatment with one of 3 doses of cannabidiol [20, 30 or 40 mg] or placebo, serum THC concentrations and its cognitive and psychological effects were not affected by CBD pretreatment).
Johnson E, Kilgore M, Babalonis S. (2022). Cannabidiol (CBD) product contamination: quantitative analysis of Δ^9^ -tetrahydrocannabinol (Δ^9^-THC) concentrations found in commercially available CBD products. Drug Alcohol Depend. (Among 80 samples of commercially purchased CBD [from local or online retailers, some labelled as THC-free], 51 [64%] were found to have detectable levels of THC ranging in concentration from 0.1 to 2.1 mg/mL).
EFSA Panel on Nutrition. (2022). Statement on safety of cannabidiol as a novel food: data gaps and uncertainties. EFSA J. (Major review of the mechanisms of action, clinical effects and toxicities of cannabidiol [CBD] used as a “novel food” in the European Union, difficulties being the variable purity and concentration of commercial CBD products, its uncertain mechanism of action, the lack of rigorous clinical studies of its efficacy and poor description of potential toxicities leading to the conclusion that more and better studies are needed; in animal models CBD increases the relative liver weight and has variably been found to result in transient elevations in ALT, Alk P and bilirubin; similar results have been found in healthy human volunteers, but largely in higher doses and without instances of clinically apparent liver injury).
Stolar O, Hazan A, Vissoker RE, Kishk IA, Barchel D, Lezinger M, Dagan A, et al. (2022). Medical cannabis for the treatment of comorbid symptoms in children with autism spectrum disorder: An interim analysis of biochemical safety. Front Pharmacol. (Among 59 children with autistic spectrum disorder treated with medium chain triglyceride oil with cannabidiol in escalating doses for an average of 18 weeks, there were no clinical or statistically significant changes in complete blood counts or chemistry tests including ALT, AST, Alk P).
Arnold JC, McCartney D, Suraev A, McGregor IS. (2023). The safety and efficacy of low oral doses of cannabidiol: An evaluation of the evidence. Clin Transl Sci. (Review of literature on the effects and tolerability of low doses of cannabidiol [less than 400 mg daily] as are found in widely available over-the-counter CBD products concludes that evidence for effects on anxiety, pain, lipids, sleep and muscle damage is weak, but adverse events are few and similar in incidence to those with placebo).
Grimison P, Mersiades A, Kirby A, Lintzeris N, Morton R, Haber P, Olver I, et al. (2020). Oral THC:CBD cannabis extract for refractory chemotherapy-induced nausea and vomiting: a randomised, placebo-controlled, phase II crossover trial. Ann Oncol. (Among 81 patients with refractory chemotherapy induced nausea and vomiting were treated with 1 to 4 oral cannabis extract tablets [THC 2.5 mg/CBD 2.5 mg] or placebo three times daily 1 day before and 5 days after chemotherapy in a crossover design, a complete response [no nausea or vomiting] occurred in 25% of THC/CBD treated compared to 14% of placebo treated courses; adverse events more frequent with THC/CBD included sedation, dizziness, and disorientation, but there were no cannabinoid-related serious adverse events and no mention of ALT elevations or hepatotoxicity).
Park YD, Linder DF, Pope J, Flamini JR, Moretz K, Diamond MP, Long SA. (2020). Long-term efficacy and safety of cannabidiol (CBD) in children with treatment-resistant epilepsy: Results from a state-based expanded access program. Epilepsy Behav. (Among 45 children with treatment resistant epilepsy treated with cannabidiol in an expanded access program found a reduction in seizure frequency of 61-70% compared to baseline, but with frequent adverse events including 11% with ALT or AST elevations but none were scored as serious adverse events).
Scheffer IE, Halford JJ, Miller I, Nabbout R, Sanchez-Carpintero R, Shiloh-Malawsky Y, Wong M, et al. (2021). Add-on cannabidiol in patients with Dravet syndrome: Results of a long-term open-label extension trial. Epilepsia. (Among 315 patients with Dravet syndrome [97% children] treated with cannabidiol in controlled trials who were then followed in a long term, open label extension trial for a median duration of 1.2 years and dose of 22 mg/kg daily, seizure frequency decreased by 49-84% and adverse events with frequent, ALT elevations arose in 11% most of whom were also receiving valproate, but there were no instances of liver injury with jaundice or deaths from liver disease).
Patel AD, Mazurkiewicz-Bełdzińska M, Chin RF, Gil-Nagel A, Gunning B, Halford JJ, Mitchell W, et al. (2021). Long-term safety and efficacy of add-on cannabidiol in patients with Lennox-Gastaut syndrome: results of a long-term open-label extension trial. Epilepsia. (Among 366 patients with Lennox-Gastaut syndrome who participated in randomized controlled trials of cannabidiol and were continued on therapy in an extension trial with a median follow up of 3 years, median decreases in the frequency of seizures was 48-68%, while serious adverse events arose in 42% including 55 [15%] with ALT or AST elevations above 3 times ULN, leading to discontinuation in 15 [27%], but resolved in most patients spontaneously or after reduction in doses of concomitant valproate or clobazam).
Bouquet E, Pain S, Eiden C, Jouanjus E, Richard N, Fauconneau B, Pérault-Pochat MC, French Addictovigilance Network. (2021). Adverse events of recreational cannabis use reported to the French Addictovigilance Network (2012-2017). Br J Clin Pharmacol. (Among 2217 patients enrolled in a French vigilance registry of addiction involving cannabis use between 2012 and 2017, most were men [76%], and 18 to 34 years old [57%], the most frequent adverse events were psychiatric [51%], neurological [37%], cardiac [8%], and cannabinoid hyperemesis syndrome [3%], with only 3 being hepatobiliary events [abscess, sclerosing cholangitis and “cytolysis”], with no unexpected hepatic events, or deaths from liver disease).
Iannone LF, Arena G, Battaglia D, Bisulli F, Bonanni P, Boni A, Canevini MP, et al., CBD LICE Italy Study Group. (2021). Results from an Italian expanded access program on cannabidiol treatment in highly refractory Dravet syndrome and Lennox-Gastaut syndrome. Front Neurol. (Among 93 Italian patients with Dravet or Lennox-Gastaut syndrome enrolled in an open label study of cannabidiol, 40% had a 50% or greater decrease in seizures but adverse events arose in 52%, most commonly somnolence [23%] and diarrhea [12%] and ALT or AST elevations above 3 times ULN [11%], and hyperammonemia [8%] usually in patients who were also taking valproate; no episodes of clinically apparent liver injury).
Watkins PB, Church RJ, Li J, Knappertz V. (2021). Cannabidiol and abnormal liver chemistries in healthy adults: results of a phase I clinical trial. Clin Pharmacol Ther. (Among 16 healthy volunteers treated with cannabidiol in doses of 1500 mg daily for 3 to 4 weeks, 7 [44%] developed ALT elevations which were greater than 5 times ULN in 5 [31%] beginning with 2-4 weeks and resolving rapidly with discontinuation; no mention of bilirubin elevations but alkaline phosphatase elevations occurred as well and some patients developed symptoms or signs of hepatitis including fever, nausea, abdominal discomfort, and eosinophilia).
Yan K, Forman L. (2021). Cannabinoid use among liver transplant recipients. Liver Transpl. (Among 1227 liver transplant recipients, 538 responded to an exploratory survey on cannabinoid use, 24% were using marijuana [72% smoking, 47% daily use] and 21% were using CBD, usually for relieving pain [85%] and anxiety [31%]; the effects of liver tests and transplant outcomes could not be assessed).
Szaflarski JP, Devinsky O, Lopez M, Park YD, Zentil PP, Patel AD, Thiele EA, et al. (2023). Long-term efficacy and safety of cannabidiol in patients with treatment-resistant epilepsies: four-year results from the expanded access program. Epilepsia. (Among 840 patients in a long term open labelled extension study of cannabidiol for refractory seizures treated for a median duration of 1.9 years and dose of 25 mg/kg daily, the reduction in seizure frequency was 50-66% and adverse events arose in 88% resulting in discontinuation in 7% of patients, the most common events being diarrhea, seizures, somnolence with ALT elevations above 5 times ULN in 3%, resolving in all spontaneously or with dose reduction or discontinuation and without jaundice; among 20 deaths none were due to liver failure).
Pillai M, Erridge S, Bapir L, Nicholas M, Dalavaye N, Holvey C, Coomber R, et al. (2022). Assessment of clinical outcomes in patients with post-traumatic stress disorder: analysis from the UK Medical Cannabis Registry. Expert Rev Neurother. (Among 162 patients enrolled in the UK Medical Cannabis Registry who were treated for posttraumatic stress disorder, improvements in PTSD symptoms occurred with therapy and adverse events were reported in 20% of patients including fatigue, insomnia and dizziness but with no reports of liver injury).
Vickery AW, Roth S, Ernenwein T, Kennedy J, Washer P. (2022). A large Australian longitudinal cohort registry demonstrates sustained safety and efficacy of oral medicinal cannabis for at least two years. PLoS One. (Among 3961 patients in an Australian longitudinal registry of patients treated with medicinal cannabis for at least 2 years, improvements in symptoms were rapid and sustained for two, during which 37% had at least one adverse event including somnolence [11%], dry mouth [9%], lethargy [6%], dizziness [6%] and nausea [5%], without mention of liver related adverse events or ALT elevations).
Thiele EA, Bebin EM, Filloux F, Kwan P, Loftus R, Sahebkar F, Sparagana S, et al. (2022). Long-term cannabidiol treatment for seizures in patients with tuberous sclerosis complex: An open-label extension trial. Epilepsia. (Among 199 patients with the tuberous sclerosis complex and refractory seizures enrolled in a long term open label extension trial of cannabidiol therapy, the median reduction in seizure frequency ranged from 54-68% and common adverse events included diarrhea [42%], decreased appetite [20%], and ALT or AST elevations above 3 times ULN [9%] that usually arose within 3 months and resolved without jaundice either spontaneously, with dose reduction, or stopping other anticonvulsants, requiring discontinuation in only 1 patient).
Gelow K, Chalasani S, Green K, Lammert C. (2022). Utilization and impact of complementary and alternative medicines in symptomatic autoimmune hepatitis patients. Dig Dis Sci. (Among patients with autoimmune hepatitis who completed an online questionnaire, 45% reported using CBD oil after the diagnosis was made usually for fatigue, pain, disturbed sleep, or itching).
Olsson F, Erridge S, Tait J, Holvey C, Coomber R, Beri S, Hoare J, et al. (2023). An observational study of safety and clinical outcome measures across patient groups in the United Kingdom Medical Cannabis Registry. Expert Rev Clin Pharmacol. (Among 2833 persons enrolled in the UK Medical Cannabis Registry between 2019 and 2022, indications for treatment included non-cancer pain [32%], anxiety [11%], fibromyalgia [11%], neuropathy [8%]. PTSD [6%] and depression [5%], health related quality of life improved after 1 month and was improved in all subscales except self-care at 12 months, the most common therapies were THC oil [20 mg/mL] and CBD oil [50 mg/mL]; adverse events being reported by 17% of patients which were usually mild or moderate [79%], most commonly fatigue [14%], dry mouth [12%], somnolence [11%] insomnia [11%] headache [10%], impaired concentration [10%], nausea [9%], and dizziness [8%]; no mention of ALT elevations or liver injury).
Morris M, Chye R, Liu Z, Agar M, Razmovski-Naumovski V. (2023). A retrospective medical record review of adults with non-cancer diagnoses prescribed medicinal cannabis. J Clin Med. (Among 157 adults treated with medicinal cannabis [typically balanced THC/CBD oil] at a single specialty clinic after its approval in Australia, the major reasons were for pain [87%], muscle spasm [12%] and sleep [6%] and its was considered beneficial by the patient in 54%, most frequently for neuropathy [67%], Parkinson disease [61%], multiple sclerosis [60%], migraine [44%], chronic pain syndrome [42% and spondylosis [40%] and specifically for sleep [80%], fatigue [52%], and pain [50%]; side effects were reported in 43% of patients and were generally mild including somnolence, dry mouth and confusion; no mention of ALT elevations or liver injury).
Kühne F, Becker LL, Bast T, Bertsche A, Borggraefe I, Boßelmann CM, Fahrbach J, et al. (2023). Real world data on cannabidiol treatment of various epilepsy subtypes: a retrospective, multicenter study. Epilepsia Open. (Among 311 patients with various forms of epilepsy followed at 16 European epilepsy centers and treated with cannabidiol [2.5-45 mg/kg/day], response rates were similar across different forms of epilepsy [not just Dravet and Lennox-Gastaut syndrome], and adverse events were reported by 47% of patients, leading to discontinuation in 9%, and described as fatigue in 24%, gastrointestinal 21%, psychiatric 6%, and liver test elevations in 5 subjects, 4 of whom were also receiving valproate; positive side effects included improved mood, sleep, concentration and appetite).

## OTHER REFERENCE LINKS

1 Recent References on Cannabidiol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cannabidiol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cannabidiol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cannabidiol)